# Glossary

Acinus: The main structural unit of the liver seen under the microscope; each acinus includes liver cells, sinusoids, central and portal areas with blood vessels, lymphatics and bile ducts.
Acute fatty liver: Rapid accumulation of fat in the liver usually caused by alcohol or medications that interfere with fat metabolism. Rarely, this can occur in the last trimester of pregnancy.
Acute liver disease: Liver disease that is limited in duration, but usually with a sudden and symptomatic onset.
Acute liver failure: Serious liver failure arising suddenly in a person without previous liver disease.
Acute hepatic necrosis: Sudden severe liver (hepatic) cell death (necrosis) that is typical of toxic injury to the liver.
Adenoma: A benign tumor of the liver that can grow large and rupture, causing internal bleeding.
Adenosine triphosphate (ATP): The molecule within cells used for energy reactions.
Alanine aminotransferase (ALT): An enzyme found in the blood that is elevated with liver injury, particularly hepatocellular (formerly SGPT). This is the most sensitive indicator of injury to the liver.
Alkaline phosphatase (Alk P): An enzyme found in the blood that is elevated with liver injury, particularly cholestatic. This enzyme can also originate from other structures, like bone and bowel; if originating from the liver, other enzymes, such as the GGT, ALT, or liver fraction of the alkaline phosphatase will be abnormal.
Allogeneic: A transplant in which the recipient receives an organ or cells from another (usually related) person.
Aminotransferase: One of two enzymes (alanine or aspartate aminotransferase: ALT and AST) found in the blood that, when elevated, are sensitive indicators of liver injury.
Anicteric: Absence of jaundice (icterus).
Anorexia: Loss of appetite.
Antinuclear antibody: An antibody found in blood directed against the nucleus of cells, typically present in patients with autoimmune hepatitis.
Anti-smooth muscle antibody: An antibody found in blood directed against smooth muscles, typically present in patients with autoimmune hepatitis.
Apoptosis: Programmed cell death which is typical of the liver cell injury from hepatitis, as opposed to necrosis which is typical of toxic injury or shock.
Ascites: Accumulation of fluid in the abdominal cavity, which is usually caused by acute or chronic liver failure.
Aspartate aminotransferase (AST): An enzyme found in the blood that is elevated with liver injury, particularly hepatocellular (formerly SGOT). Although elevated in liver disease, the enzyme can originate from other organs and muscle.
Asterixis: A jerking motion of the outstretched hands that is a sign of early stages of liver coma.
Autoantibodies: Antibodies in the blood that are directed against normal body proteins or cells, such as antinuclear antibody or anti-smooth muscle antibody.
Autoimmune features: Findings suggestive of an overactive immune system, such as high antibody levels and "autoantibodies".
Autoimmune hepatitis: A chronic liver disease in which an overactive immune system appears to damage the liver.
Autologous: A transplant in which the recipient receives his/her own organ or cells.
Ballooning degeneration: A form of liver cell (hepatocyte) degeneration associated with cell swelling.
Benign postoperative cholestasis: Jaundice after major surgery that is temporary and resolves without treatment.
Bile ducts: The small conduits (ducts) in the liver that allow the flow of bile from liver cells out through gradually larger bile ducts into the intestine.
Bilirubin: The chemical breakdown product of red blood cells that is normally removed by the liver and excreted in bile. Bilirubin can accumulate in the serum and lead to detectable jaundice when there is liver injury and dysfunction, obstruction to the flow of bile, or spontaneous red cell destruction (hemolysis).
Bland cholestasis: Cholestatic liver injury with minimal or no inflammation in the liver.
Bone marrow transplantation: Replacement of a person's bone marrow with that of another person, used to treat leukemia and other severe forms of cancer or genetic disease.
Budd-Chiari syndrome: A severe liver disease caused by clotting and blockage of the large veins that drain the liver.
Celiac disease: An inherited disease of the small intestine caused by allergy to wheat (gliadin).
Cerebral edema: Swelling of the brain due to accumulation of fluid, that can occur in liver failure.
Cholangiography: An X-ray that shows the large bile ducts that drain bile from the liver into the intestine.
Cholecystectomy: A surgical operation to remove the gallbladder.
Cholecystitis: Inflammation of the gallbladder, typically causing fever, nausea, and abdominal pain.
Choledocholithiasis: Gallstones which have passed into the bile ducts.
Cholelithiasis: Gallstones in the gallbladder.
Cholestatic injury: Liver injury in which interference with bile flow and jaundice are prominent.
Cholesterol: The major form of fat in the body, most of which is produced in the liver.
Chronic liver disease: Persistent, long term liver disease often with vague or mild symptoms and slow onset. Conventionally, disease has been present for more than 6 months.
Chronic liver failure: Serious liver failure arising gradually in a person with a chronic liver disease.
Cirrhosis: Scarring and permanent injury to the liver, usually the result of chronic, long term damage.
Clinical phenotype: A pattern of clinical presentation and course of liver injury that is typical for a specific disease or injury from a specific medication.
Clinical signs: Findings on physical examination such as rash, fever, enlarged or tender liver and jaundice.
Clinical symptoms: Patient complaints such as fatigue, nausea, poor appetite, dark urine or yellow discoloration of the skin (jaundice).
Coagulopathy: Abnormal bleeding tendency which can be caused by lack of clotting factors that are made by the liver.
Collagen: The major protein found in scars and that is increased in cirrhosis of the liver.
Dark urine: Dark or tea-colored urine is a symptom of liver disease caused by elevations in serum bilirubin and secretion of bilirubin in the urine.
Dietary Supplements: Dietary supplements contain one or more dietary ingredients such as vitamins, minerals, herbals or other botanicals, amino acids or organ extracts that are intended to supplement the diet.
Ductopenia: Finding on liver histology of a decrease or lack of small bile ducts in the liver.
Ductules: The smallest bile ducts that can be seen on liver histology.
Edema: Tissue swelling of the feet, ankles or other parts of the body caused by abnormal accumulation of fluid which can be the result of heart, kidney or liver failure.
Eosinophilia: Increased eosinophils in the blood (the white blood cells that are active in allergic reactions).
Elastography: A noninvasive X-ray method of measuring stiffness of the liver, which is increased with advancing fibrosis and cirrhosis.
Encephalopathy: Mental confusion and altered level of consciousness that can occur in liver failure.
Endothelial cell: The cells in the liver that line the blood channels (sinusoids).
Esophagus: The muscular swallowing tube that runs from the mouth to the stomach.
Fatty acid: The breakdown product of triglycerides and fat that are taken up by the liver and used as a source of energy or to make triglycerides.
Fibrosis: The presence of scarring in the liver, usually shown by liver biopsy histology.
Focal nodular hyperplasia: A benign tumor of the liver.
Gamma glutamyl transpeptidase (GGT): An enzyme found in the blood that is elevated with liver injury, particularly cholestatic. This is also commonly elevated in recent alcohol consumption.
Glutathione: A substance made in the liver that binds to and helps remove drugs and toxins.
Glycogen: The principal storage form of glucose (sugar) in the liver.
Granulomatous hepatitis: Liver injury in which granulomas (small collections of inflammatory cells) are found in the liver biopsy.
Graves' disease: A disease of the thyroid (hyperthyroidism)
Hepatic encephalopathy: Confusion, mental dullness, drowsiness and even coma caused by liver failure.
Hepatitis A: Infectious liver disease, spread primarily through the fecal-oral route, caused by the hepatitis A virus; now preventable by vaccine. Most people recover and the infection does not become chronic.
Hepatitis B: Infectious liver disease caused by the hepatitis B virus, spread primarily through sexual contact or through perinatal (vertical) transmission; now preventable by vaccine. Approximately 5% of acute hepatitis B cases become chronic.
Hepatitis C: Infectious liver disease caused by the hepatitis C virus for which there is no vaccine and which commonly becomes chronic; now the most common cause of cirrhosis in the United States.
Hepatitis D: Rare but severe liver disease caused by the hepatitis D virus, which only affects persons who are also infected with hepatitis B.
Hepatitis E: Infectious form of viral hepatitis that is rare in the United States but common in the developing world; may also be spread by contact with pigs or wild boar.
Hepatocellular injury: Liver injury in which liver cell damage and inflammation are prominent.
Hepatocyte: The major cells in the liver responsible for its function.
Hepatotoxicity: Toxin injury to the liver due to a medication, chemical, herbal or dietary supplement; another term for drug induced liver injury.
Hemangioma: A benign tumor of the liver.
Hematopoietic cell transplantation: Transplantation of blood elements such as bone marrow or stem cells.
Hepatic venous pressure gradient: A diagnostic measurement of the pressure inside the veins of the liver that is increased in cirrhosis.
Hepatomegaly: Enlargement of the liver.
Hyperammonemia: High levels of ammonia in the blood which can occur in liver failure.
Hyperlipidemia: Abnormally high levels of lipids (cholesterol, triglycerides) in the blood.
Hyperthermia: Abnormally high body temperature, usually due to heat shock, which can cause liver injury.
Hypotension: Abnormally low blood pressure, which can cause liver injury (ischemic hepatitis).
Hypoxia: Low oxygen tension in the blood which can cause liver injury (ischemic hepatitis).
Icteric: Presence of jaundice, which is typically first evident in the whites of the eyes (sclera) followed by skin.
Icterus: Another name for jaundice, used to describe a yellowish tinge to the skin and eyes.
Idiopathic: A medical term meaning "of unknown cause".
Immunoallergic hepatitis: Liver injury with prominent features of allergy or hypersensitivity. Typically, this includes fever, rash, and/or hives.
Immunoglobulin: A class of blood proteins that include antibodies.
Interlobular bile ducts: The larger bile ducts in the liver that allow the flow of bile from intralobular bile ducts to the larger bile ducts that, ultimately, direct bile to the gallbladder and intestine.
Intralobular bile ducts: The small conduits (ducts) in the liver than allow the flow of bile from liver cells to the larger, interlobular bile ducts.
Ischemic hepatitis: Severe hypotension (shock), lack of oxygen (anoxia), or sudden heart failure that leads to decreased blood flow to the liver; usually resolves quickly if the sudden insult is corrected.
Itching: Irritating skin sensation that provokes scratching, a symptom of liver disease, particularly cholestatic (also known as "pruritus").
Jaundice of sepsis: Jaundice occurring in the setting of severe bacterial infections (sepsis) that resolves if the infection in treated; liver biopsy shows prominent cholestasis.
Jaundice: Yellowish tinge to the skin or whites of the eyes caused by elevation in bilirubin in the blood; also called "icterus".
Lactic acidosis: High levels of lactic acid in the blood, usually caused by failure of mitochondrial function in the liver.
Large bile ducts: The bile ducts in the liver (right and left hepatic duct) and outside of the liver (common bile duct) allow the flow of bile to the gallbladder and intestine.
Latency: The duration between ingestion, or exposure, to a drug, toxin, or infectious agent and the onset of disease.
Likelihood score: A 5-point scale [A to E] that estimates whether a medication is a of cause liver injury: A=Well known cause; B=Highly likely cause; C=Probable cause; D=Possible cause; E=Unlikely cause; E*=Suspected but unproven cause; X=Unknown.
Liver histology: Findings on microscopic assessment of a liver biopsy.
Liver inflammation: Findings of white blood cells (inflammatory cells) in the liver on microscopic assessment of a liver biopsy.
Liver test abnormalities: Blood tests results that indicate liver injury such ALT, AST, alkaline phosphatase, bilirubin, albumin and prothrombin time (or INR).
Liver transplantation: Replacement of a person's liver with that of another person, used to treat end stage liver disease, acute liver failure, liver cancer and rare genetic disorders.
Lymphocyte: A type of white blood cell that is responsible for immune responses.
Macrophage: A large cell found in the liver that engulfs foreign material and takes part in inflammation.
Macrovesicular fat: Abnormal large droplets of fat found in liver cells; typically, the nucleus is pushed to one side of the cell by fat droplets.
Mallory bodies: Abnormal twisted rope-like bodies seen by microscope in fatty liver disease.
Matrix: The proteins that surround and support cells.
Microvesicular fat: Abnormal numbers of small droplets of fat in liver cells; typically, the nucleus remains in the center of the cell.
Mitochondria: A component found in all living cells that is responsible for producing energy and is essential for health.
Mixed injury: Liver injury with features of both hepatocellular and cholestatic injury.
Monoclonal antibody: Antibodies produced in mice that are highly specific for a single protein or substance, which can be used to treat serious diseases such as cancer (rituximab) or arthritis (infliximab).
Mononucleosis: Acute illness caused by the Epstein Barr virus that can cause liver disease that resembles acute viral hepatitis.
Mononucleosis: Acute illness caused by the Epstein Barr virus that can cause liver disease that resembles acute viral hepatitis.
M & V Scale: A causality assessment method similar to RUCAM developed by Drs. Maria and Victorino.
Myeloablation: Deliberate destruction of the bone marrow by chemotherapy, done in preparation of bone marrow transplantation.
Myopathy: Disease of the muscles.
Naranjo Scale: A causality assessment method for assessing all forms of drug induced adverse events.
Neuropathy: Disease of the brain, nerves or nervous system.
Neutropenia: Decrease in neutrophils, a white blood cell important in defense against infections.
Neutrophil: A white blood cell which is an important defense in bacterial infections.
Nodular regenerative hyperplasia: Unusual transformation of the normal liver structure into nodules. Typically, there is little or no scar tissue, differentiating this from cirrhosis.
Nonparenchymal: A liver histology term referring to those parts of the liver other than the major hepatocytes (liver cells) including the endothelial cells, macrophages, veins, arteries and bile ducts.
Nystagmus: Involuntary jerking motion of the eyes that occurs with brain injury and liver coma.
Optic neuritis: Inflammation of the nerves of the eye, which can cause blindness.
Pancreatitis: Inflammation and injury of the pancreas.
Parenchymal: A liver histology term referring to the part of the liver with hepatocytes (liver cells) as opposed to the areas with supporting cells, veins, arteries and bile ducts.
Percutaneous liver biopsy: A liver biopsy that is done by passing a needle through the skin into the liver.
Plasma cell: A cell that makes antibodies, which is often found in liver inflammation caused by autoimmune reactions.
Portal hypertension: Abnormally increased pressure in the portal vein that delivers blood from the intestine to the liver, which is caused by cirrhosis and can result in bleeding and fluid retention (ascites).
Portal inflammation: Findings of inflammatory cells on liver biopsy in areas around the veins, arteries and bile ducts entering the liver.
Primary biliary cirrhosis: A chronic liver disease marked by gradual autoimmune loss of bile ducts leading ultimately to cirrhosis.
Primary sclerosing cholangitis: A chronic autoimmune disease marked by damage and loss of the large bile ducts that can lead to liver damage and cirrhosis.
Prodromal: In acute liver disease, the period of symptoms, frequently vague, immediately before appearance of jaundice.
Prognosis: Prediction or likelihood of an outcome (good or bad) of an illness.
Prothrombin time: A measure of clotting ability that becomes abnormal (prolonged) with liver failure.
Pruritus: Itchiness of the skin, a symptom of liver disease, particularly cholestatic.
Radio-mimetic: Resembling radiation effects.
Rechallenge: Reexposure, deliberate or accidental, of a patient to a medication that was believed to have caused an adverse side effect, such as drug induced liver injury.
Reticulin: A stain used on liver biopsies to visualize elastic fibers.
Reye's syndrome: An acute and severe liver disease of children that follows an acute viral illness and aspirin use.
RUCAM: The Roussel Uclaf Causality Assessment Method for evaluating the likelihood that a medication has caused drug induced liver injury.
R value: The ratio of alanine aminotransferase (ALT) to alkaline phosphatase (Alk P) values, both expressed as multiples of the upper limit of normal. An R value of >5.0 is used to define hepatocellular injury, R <2.0 as cholestatic injury, and R between 2.0 to 5.0 as mixed hepatocellular-cholestatic injury.
Sinusoids: The small passages between liver cells in which blood flows from the portal areas to the central veins.
Sinusoidal-obstruction syndrome (SOS): Liver histology findings indicating a blockage of blood flow out of the liver.
Splenomegaly: Enlargement of the spleen.
Status epilepticus: Persistent, uninterrupted seizures.
Steatohepatitis: Excess fat with inflammation and damage in the liver.
Steatosis: An abnormal amount of fat in the liver.
Stellate cells: Fat storing cells in the liver that make collagen (fibrosis).
Stevens-Johnson syndrome: Sudden onset of fever and severe body rash often due to an allergic reaction to a medication.
Synthesis: Production or making of a substance.
Tachycardia: Rapid heart rate.
Tachypnea: Rapid breathing rate.
Thrombocytopenia: Abnormal decrease in the numbers of blood platelets, which are small elements needed for clotting.
Transjugular liver biopsy: A liver biopsy that is done by passing a needle in a flexible tube from a vein in the neck into the liver.
Triglycerides: One of the major forms of fat that is produced in the liver and found in the blood.
Varices: Abnormal, large veins that are found in the esophagus and intestine when there is portal hypertension.
Vanishing bile duct syndrome (VBDS): A chronic form of liver disease in which there is a gradual loss of small bile ducts in the liver (ductopenia).
Veno-occlusive disease (VOD): Another term for "sinusoidal-obstruction syndrome" or liver histology findings indicating a blockage of blood flow out of the liver.
Vinyl chloride: Chemical used in manufacturing that can harm the liver.
Viral hepatitis: Liver disease caused by one of 5 hepatitis viruses (A, B, C, D or E).
Wilson disease: An inherited disease marked by accumulation of copper in the liver, brain and other tissues that can cause cirrhosis and be fatal if not detected early and treated.